# Nefazodone

## OVERVIEW

### Introduction

Nefazodone is a serotoninergic modulating antidepressant that is used in therapy of depression, aggressive behavior and panic disorder. Nefazodone therapy has been associated with transient, usually asymptomatic elevations in serum aminotransferase levels and has been linked to several instances of clinically apparent acute liver injury some of which have been fatal.

### Background

Nefazodone (ne faz' oh done) is a phenylpiperazine derivative whose mechanism of action is believed to be inhibition of serotonin and norepinephrine reuptake, which results in increased levels and activity of these neurotransmitters. However, the actual mechanism of action is unknown and nefazodone also is a weak serotonin and alpha-1 adrenergic antagonist. Nefazodone was approved for use in moderate and severe depression in the United States in 1988, but was subsequently linked to many cases of acute liver injury, some of which were fatal, and is no longer in common use. Current indications are for major depression that has not responded to conventional antidepressants where the risks of liver failure are discussed fully with the patient and considered warranted. Nefazodone is available in tablets of 50, 100, 150, 200 and 250 mg in several generic forms and formerly under the brand name of Serzone. The recommended dosage for depression in adults is 200 mg daily that can be increased in 100 mg amounts to a maximum of 600 mg daily. Common side effects of nefazodone are drowsiness, dizziness, headache, dry mouth, blurred vision, nausea, constipation or diarrhea, decreased libido, abnormal dreams, increased appetite and weight gain. Uncommon but potentially severe adverse events include suicidal thoughts and behaviors, activation of mania, serotonin syndrome, seizures, priapism, angle closure glaucoma, and severe hypersensitivity reactions including angioedema and Stevens Johnson syndrome.

### Hepatotoxicity

Liver test abnormalities occur in a proportion of patients on nefazodone, but elevations are usually modest and usually do not require dose modification or discontinuation. Soon after its general availability, nefazodone was linked to several instances of acute, clinically apparent liver injury, some of which were fatal. The onset of injury varied from 6 weeks to 8 months and the pattern of serum enzyme elevations was typically hepatocellular. Autoimmune (autoantibodies) and immunoallergic features (rash, fever, eosinophilia) were uncommon. Liver biopsy usually demonstrated an acute hepatitis with cholestasis and variable degrees of centrolobular (zone 3) necrosis. Systematic reviews suggested that the incidence of hepatic failure due to nefazodone is 1 per 250,000 to 300,000 patient-years of exposure. Because of this complication, nefazodone was withdrawn from use in many countries. Nefazodone, however, can be effective in patients with otherwise resistant forms of severe depression. For this reason, it remains available in the United States with the recommendation that it be used only if other antidepressants have been found to be ineffective and after full disclosure and discussion of the risks. It has a “black box” warning for hepatotoxicity.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which nefazodone causes liver injury is not known. Nefazodone is extensively metabolized by the liver, mainly via the cytochrome P450 system (CYP3A4), and hepatotoxicity may be mediated by toxic intermediates of its metabolism. Nefazodone is also susceptible to multiple drug-drug interactions and doses of concurrent medications should be carefully chosen.

### Outcome and Management

The serum aminotransferase elevations that occur on nefazodone therapy are usually self-limited, but require careful monitoring if they arise because of the risk of clinically apparent liver injury, which can be severe and even fatal. Several instances of acute liver failure have been attributed to nefazodone therapy and it is often mentioned in case series of acute liver failure due to medications. While routine monitoring of liver tests is not recommended with nefazodone therapy, monitoring for signs and symptoms of liver injury (and full explanation of the meaning of such symptoms to the patient) is strongly recommended. Persons with intolerance to nefazodone may have similar reactions to other antidepressants and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents, Miscellaneous

Other Drugs in the Subclass: Trazodone

## CASE REPORT

### Case 1. Acute liver failure due to nefazodone.(1)

A 52 year old man developed fatigue and nausea 6 weeks after starting nefazodone (300 mg daily) for a long standing depression that had not responded adequately to conventional antidepressants. He had no previous history of liver disease, did not drink alcohol and had no risk factors for viral hepatitis. His liver enzymes were known to be normal in the past. Other medications included an herbal sleeping aid (valerian and passionflower) and ergotamines for occasional headaches. Laboratory test results included marked elevations in serum aminotransferase levels (ALT 1947 U/L, AST 836 U/L), with minimal increases in GGT (88 U/L) and normal bilirubin levels. All medications were stopped and he was observed. Over the next week, he became jaundiced and his prothrombin index (Quick) fell (from 53% of normal to 27%). He was transferred to a liver transplant center. Tests for hepatitis A, B and C were negative as were serologic tests for acute cytomegalovirus, herpes simplex and Ebstein Barr Virus infection. Abdominal imaging initially showed a normal appearing liver, but a slight amount of ascites. Two weeks later, magnetic resonance imaging demonstrated a shrunken liver and worsening ascites. A liver biopsy showed a cellular and canalicular cholestasis with marked portal inflammation and periportal necrosis and fibrosis with lobular collapse. He remained markedly jaundiced and developed marked ascites and hepatic encephalopathy. Fourteen weeks after starting nefazodone and 8 weeks after stopping it, he underwent liver transplantation. Despite this, he developed postoperative complications and died of disseminated aspergillosis 4 weeks later.

#### Key Points

Medication: | Nefazodone (300 mg daily)
Pattern: | Hepatocellular (R=26)
Severity: | 5+ (liver transplantation, death)
Latency: | 6 weeks
Recovery: | None
Other medications: | Passionflower, valerian, ergotamines

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | GGT (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 21 | 26
5 weeks | Pre | Normal | Normal | Normal
6 weeks | 0 | 1947 | 88 | Normal | Admission
7 weeks | 7 days | 1031 | 89 | 13.9 | Transfer to transplant center
| 8 days | 1108 | 85 | 18.9 | Prothrombin time: 30%
9 weeks | 3 weeks | 87 | 29 | 34.9
10 weeks | 4 weeks | 45 | 28 | 41.4
12 weeks | 6 weeks | 22 | 11 | 41.4 | Encephalopathy
14 weeks | 8 weeks | 14 | 18 | 43.9 | Prothrombin time 25%
| 8 weeks | Liver transplantation
Normal Values | | <25 | <29 | <1.2

#### Comment

Nefazodone has been linked to many instances of severe acute hepatocellular injury arising 2 to 24 weeks after starting therapy. The injury is typically hepatocellular and can be severe. Autoimmune and immunoallergic features are not common. In the current instance, nefazodone was discontinued promptly, but the liver injury was severe enough that hepatic failure arose that did not resolve over the next 4 to 8 weeks, leading to a liver transplant but subsequent death from complications. The sleeping aid that was started at the same time as nefazodone is a commonly used herbal mixture that has not been specifically linked to liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nefazodone – Generic, Serzone®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=NEFAZODONE+HYDROCHLORIDE)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nefazodone | 82752-99-6 | C25-H32-Cl-N5-O2.Cl-H

## CITED REFERENCES

1 Ehrentraut S, Rothenhäusler HB, Gerbes AL, Rau HG, Thiel M, Schirren CA, Kapfhammer HP. (2002). Nervenarzt.

## ANNOTATED BIBLIOGRAPHY

References updated: 26 February 2020

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; trazodone is discussed but not nefazodone which had been approved just the year before).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that 15 cases of liver injury due to nefazodone have been published including 3 of "subfulminant hepatitis").
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-78. (Textbook of pharmacology and therapeutics).
Robinson DS, Roberts DL, Smith JM, Stringfellow JC, Kaplita SB, Seminara JA, Marcus RN. (1996). The safety profile of nefazodone. J Clin Psychiatry. (Pooled analysis of 3500 patients on nefazodone in clinical trials conducted in support of its approval for use in major depressive disorders; most common side effects were nausea, somnolence, dry mouth, dizziness, constipation and asthenia; 12% stopped drug for side effects vs 7.5% on placebo, 10.5% fluoxetine and 22% imipramine; no excess weight gain or abnormal laboratory tests vs placebo; of note, no deaths or severe side effects due to liver injury and no mention of ALT elevations).
Lucena MI, Andrade RJ, Gomez-Outes A, Rubio M, Cabello MR. (1999). Acute liver failure after treatment with nefazodone. Dig Dis Sci. (73 year old woman developed abdominal pain 7 weeks after starting nefazodone [bilirubin 17.1 mg/dL, ALT 834 U/L, Alk P 115 U/L, protime 15 sec], with progressive liver failure and death 4 weeks after presentation).
Aranda-Michel J, Koehler A, Bejarano PA, Poulos JE, Luxon BA, Khan CM, Ee LC, et al. (1999). Nefazodone-induced liver failure: report of three cases. Ann Intern Med. (Three women, ages 54, 16 and 57 years, developed jaundice 8, 3 and 6 months after starting nefazodone [bilirubin 34.0, 22.5 and 11.8 mg/dL, ALT 2040, 1345 and 1625 U/L, Alk P 97, 206 and 273 U/L], biopsies showing massive and centrilobular necrosis; 1 died, 1 recovered and 1 was transplanted).
van Battum PL, van de Vrie W, Metselaar HJ, Verstappen VM, Zondervan PE, de Man RA. (2000). Ned Tijdschr Geneeskd. (50 year old man developed acute liver failure 7 months after starting nefazodone).
Schirren CA, Baretton G. (2000). Nefazodone-induced acute liver failure. Am J Gastroenterol. (52 year old man developed jaundice 5-6 weeks after starting nefazodone, with ascites and liver failure requiring liver transplantation 6 weeks after presentation; explant showed massive hepatic necrosis).
Eloubeidi MA, Gaede JT, Swaim MW. (2000). Reversible nefazodone-induced liver failure. Dig Dis Sci. (46 year old woman developed fatigue followed by jaundice ~4 months after starting nefazodone [bilirubin 14.5 mg/dL, ALT 456 U/L, Alk P 158 U/L], resolving within 4 months of stopping).
Fernandes NF, Martin RR, Schenker S. (2000). Trazodone-induced hepatotoxicity: a case report with comments on drug-induced hepatotoxicity. Am J Gastroenterol. (39 year old woman developed jaundice 18 months after starting trazodone [bilirubin 11.0 mg/dL, ALT 1092 U/L and Alk P 206 U/L], improving rapidly upon stopping but recurring with inadvertent rechallenge).
Ehrentraut S, Rothenhäusler HB, Gerbes AL, Rau HG, Thiel M, Schirren CA, Kapfhammer HP. (2002). Nervenarzt. (52 year old man developed acute liver failure 6 weeks after starting nefazodone [bilirubin 13.9 mg/dL, ALT 1947 U/L, GGT 88 U/L], progressing to hepatic failure requiring liver transplantation, dying of subsequent complications: Case 1).
Stewart DE. (2002). Hepatic adverse reactions associated with nefazodone. Can J Psychiatry. (Analysis of Canadian Adverse Drug Reaction database found 32 cases of liver injury associated with nefazodone with onset after 1 week to 2 years, mostly within 6 months, 3 with hepatic failure).
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI. (2002). Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999 identified 99 cases; among SSRIs, 26 due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine, 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate ~1-3 per 100,000 patient-years of exposure, except for nefazodone=29/100,000).
Lucena M, Carvajal A, Andrade R, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; nefazodone has the highest incidence of hepatotoxicity among antidepressants and the worst prognosis).
Choi S. (2003). Nefazodone (Serzone) withdrawn because of hepatotoxicity. CMAJ. (Editorial announcing withdrawal of nefazodone in Canada; 51 Canadian reports of adverse hepatic events, 2 requiring transplant).
Tzimas GN, Dion B, Deschênes M. (2003). Early onset, nefazodone-induced fulminant hepatic failure. Am J Gastroenterol. (Two cases of acute liver failure in 61 and 46 year olds, with onset of jaundice 3 and 4 weeks after starting nefazodone with liver failure and encephalopathy, one requiring liver transplant and one with spontaneous survival).
Spigset O, Hägg S, Bate A. (2003). Hepatic injury and pancreatitis during treatment with serotonin reuptake inhibitors: data from the World Health Organization (WHO) database of adverse drug reactions. Int Clin Psychopharmacol. (Among 27,542 reports of hepatic injury in WHO database, 786 were related to SSRIs [3%], including citalopram 42, fluoxetine 222, fluvoxamine 54, paroxetine 191, sertraline 112, nefazodone 91 and venlafaxine 74, only nefazodone has an excess of hepatic reports in relationship to total reports).
Conway CR, McGuire JM, Baram VY. (2004). Nefazodone-induced liver failure. J Clin Psychopharmacol. (51 year old man developed jaundice and confusion 7 months after starting nefazodone and 1 week after a dose increase [bilirubin 1.7 mg/dL, ALT 1964 U/L, Alk P 96 U/L], resolving rapidly upon stopping).
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. (2004). Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event; hepatic in 0.05%).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, only four being due to antidepressants: nefazodone [2], bupropion [1], and paroxetine [1]).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al., Spanish Group for the Study of Drug-Induced Liver Disease. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. (Reports to a Spanish network found 461 cases of drug induced liver disease; antidepressants accounted for 23 cases [5%]).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; no antidepressant ranked among the top 21 agents that were linked to at least 50 cases each).
Kostrubsky SE, Strom SC, Kalgutkar AS, Kulkarni S, Atherton J, Mireles R, Feng B, et al. (2006). Inhibition of hepatobiliary transport as a predictive method for clinical hepatotoxicity of nefazodone. Toxicol Sci. (Nefazodone, unlike trazodone, is a potent inhibitor of the bile salt export protein [BSEP] in cell culture).
DeSanty KP, Amabile CM. (2007). Antidepressant-induced liver injury. Ann Pharmacother. (Review of drug induced liver injury and reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, antidepressants accounted for 12 cases [4%]: duloxetine [6], bupropion [2], fluoxetine [2], amitriptyline [1], sertraline [1]; no mention of trazodone or nefazodone).
Detry O, Delwaide J, De Roover A, Hans MF, Delbouille MH, Monard J, Honore P. (2009). Fulminant hepatic failure induced by venlafaxine and trazodone therapy: a case report. Transplant Proc. (48 year old woman developed jaundice and liver failure, and underwent liver transplantation, following combined therapy of venlafaxine and trazodone for 4 months).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 3 of which were linked to antidepressants, one each for nefazodone, fluoxetine and venlafaxine).
Sedky K, Nazir R, Joshi A, Kaur G, Lippmann S. (2012). Which psychotropic medications induce hepatotoxicity?. Gen Hosp Psychiatry. (Review of the hepatotoxicity of psychotropic drugs in common use, mentions that nefazodone has a "black box" warning and that liver failure occurs at a rate of 1:250,000-300,000 patient years of exposure).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of drug induced liver injury due to antidepressants, including trazodone and nefazodone).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to nefazodone or trazodone).
Montastruc F, Scotto S, Vaz IR, Guerra LN, Escudero A, Sáinz M, Falomir T, et al. (2014). Hepatotoxicity related to agomelatine and other new antidepressants: a case/noncase approach with information from the Portuguese, French, Spanish, and Italian pharmacovigilance systems. J Clin Psychopharmacol. (Among adverse event reports attributed to antidepressants submitted to 4 European pharmacovigilance databases, 3300 [10%] were for hepatotoxicity, rates being highest for agomelatine [14.6%], but also being high for mirtazapine in some databases, 2.0-11.8%; nefazodone results were available only for Spain which reported 4 cases, but the drug was withdrawn in 2003 before the study was completed]).
Voican CS, Corruble E, Naveau S, Perlemuter G. (2014). Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry. (Review of the hepatotoxicity of antidepressants mentions that aminotransferase elevations arise in 0.5-3.0% of patients, being highest with MAO inhibitors and lower with SSRIs; all antidepressants have the potential to cause liver injury but is highest with nefazodone, imipramine, amitriptyline, duloxetine, bupropion, trazodone and agomelatine).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, only one was due to an antidepressant [amitriptyline] and none to nefazodone).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2.2%] were attributed to antidepressants, but only one was due to nefazodone).
Gahr M, Zeiss R, Lang D, Connemann BJ, Schönfeldt-Lecuona C. (2015). Hepatotoxicity associated with agomelatine and other antidepressants: disproportionality analysis using pooled pharmacovigilance data from the Uppsala Monitoring Centre. J Clin Pharmacol. (Using data on adverse drug reaction reports from the Uppsala Monitoring Center of WHO, there were higher relative hepatotoxicity reports for nefazodone, agomelatine, many tricyclics and mirtazapine).
Gahr M, Zeiss R, Lang D, Connemann BJ, Hiemke C, Schönfeldt-Lecuona C. (2016). Drug-Induced Liver Injury Associated with antidepressive psychopharmacotherapy: an explorative assessment based on quantitative signal detection using different MedDRA terms. J Clin Pharmacol. (Using data on adverse drug reaction reports from the Uppsala Monitoring Center of WHO, there were higher relative hepatotoxicity reports for nefazodone, agomelatine, many tricyclics and mirtazapine).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Among 184,234 psychiatric inpatients from 80 hospitals in German-speaking European countries, 149 cases [0.08%] of drug induced liver injury were reported including 104 that imputed a single agent, the type of agent being tri- or tetra-cyclics in 50, SSNRs in 25, and SSRIs in 8, the most common single agent being mirtazapine [39 among 43,902 patients exposed: 0.09%]; nefazodone not included in the analysis as it was no longer being used).
Chen VC, Lin CF, Hsieh YH, Liang HY, Huang KY, Chiu WC, Lee Y, McIntyre RS, et al. (2017). Hepatocellular carcinoma and antidepressants: a nationwide population-based study. Oncotarget. (Among almost 50,000 cases of hepatocellular carcinoma registered in the Taiwan National Health Insurance Research Database, the rate of antidepressant use was lower than in approximately 250,000 matched controls from the database).
Bunchorntavakul C, Reddy KR. (2017). Drug hepatotoxicity: newer agents. Clin Liver Dis. (Review of hepatotoxicity of recently approved medications mentions that liver injury in recently approved agents and only rare instances have been linked to antidepressant use, highest rates associated with duloxetine, although instances of severe hepatitis and acute liver failure have been reported with nefazodone and trazodone).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an Italian prospective study between 2010 and 2014, 17 had been exposed to antidepressants including citalopram [n=4], sertraline [n=3], amitriptyline [n=3] and paroxetine [n=2], and mirtazapine [n=1], and another was exposed to both trazodone and mirtazapine; none had received nefazodone which had been withdrawn in Italy).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. (2018). Antidepressants and hepatotoxicity: a cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs. (Using the French National Health Insurance Database, 382 serious liver injuries were found in approximately 5 million persons initiating antidepressant therapy between 2010 and 2015, rates being 32.8 per 100,000 with mirtazapine, 22.2 with venlafaxine, 19.2 for SSRIs and 12.6 with duloxetine; nefazodone was not listed as it had been withdrawn from use before the period of analysis).
Pladevall-Vila M, Pottegård A, Schink T, Reutfors J, Morros R, Poblador-Plou B, Timmer A, et al. (2019). Risk of acute liver injury in agomelatine and other antidepressant users in four European countries: a cohort and nested case-control study using automated health data sources. CNS Drugs. (Analysis of data sources from 4 European countries identified 3.2 million persons initiating antidepressant therapy among whom there was no increased risk for acute liver injury for agomelatine compared to citalopram, an SSRI with a low rate of hepatotoxicity; nefazodone not included in the analysis).
Schwasinger-Schmidt TE, Macaluso M. (2019). Other antidepressants. Handb Exp Pharmacol. (Review of the pharmacology of antidepressants mentions that transient elevations in cholesterol and liver function tests can occur on mirtazapine therapy; nefazodone not discussed).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for depression; hepatotoxicity is mentioned only for nefazodone [now rarely used because of severe hepatotoxicity] and duloxetine [in heavy drinkers]).

## OTHER REFERENCE LINKS

1 Recent References on Nefazodone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nefazodone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nefazodone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nefazodone)